# Givinostat

## OVERVIEW

### Introduction

Givinostat is an orally administered histone deacetylase inhibitor used to slow disease progression in patients with Duchenne muscular dystrophy. Givinostat is associated with a low rate of serum aminotransferase elevations during treatment but has not been linked to instances of clinically apparent liver injury.

### Background

Givinostat (jiv” in oh’ stat) is a hydroxamic acid derivative that acts as an inhibitor of zinc-dependent histone deacetylase (HDAC) enzymes and is used to prevent progression of disability in patients with Duchenne muscular dystrophy. Duchenne muscular dystrophy is an X-linked recessive genetic disease caused by mutations in dystrophin, a molecule responsible for maintenance and repair of muscle tissue. The disease is characterized by progressive muscle weakness, loss of ambulation in childhood, and respiratory failure usually requiring ventilation by age 20, and death often by the age of 30. The lack of functional dystrophin, which underlies the disease, causes a constitutive increase in histone deacetylase activity, which contributes to chronic inflammation, impaired muscle regeneration, and progressive replacement of muscle with fibrous and fatty tissue that occurs in Duchenne muscular dystrophy. By inhibiting HDAC activity, givinostat is thought to promote muscle repair and growth while reducing inflammation, fibrosis, and fatty infiltration; as such, givinostat acts directly on skeletal muscle rather than on the underlying genetic defect. Because its mechanism is not mutation specific, givinostat can be used regardless of the specific dystrophin gene variant. Givinostat was approved in the United States in 2024. It is available as an oral suspension (8.86 mg/mL) under the brand name Duvyzat. The current indication is for the treatment of Duchenne muscular dystrophy in patients 6 years of age and older. The recommended dosage is based on body weight, ranging from 22.2 mg to 53.2 mg given orally twice daily. Givinostat is also being studied in other conditions, including other muscular dystrophies and polycythemia vera. Common side effects include diarrhea, abdominal pain, nausea and vomiting, and fever, as well as laboratory abnormalities of thrombocytopenia, hypertriglyceridemia, anemia and neutropenia. Uncommon but potentially serious adverse events include dose-related thrombocytopenia with bleeding, marked hypertriglyceridemia, severe gastrointestinal disturbances with dehydration, and QTc interval prolongation, the last of which warrants avoidance in patients at increased risk for ventricular arrhythmias or on other drugs associated with prolongation of the QTc interval.

### Hepatotoxicity

Serum aminotransferase levels are elevated in most patients with Duchenne muscular dystrophy, most likely due to release of these enzymes from injured muscle rather than liver. For this reason, gamma glutamyl transpeptidase (GGT) levels are considered more reliable in assessing liver injury in this disease. In the pre-registration, controlled trial of givinostat in 179 patients (118 on givinostat, 61 on placebo) with Duchenne muscular dystrophy, GGT levels rose in only 2 givinostat-treated participants, and the elevations were transient, asymptomatic, and mild-to-moderate in severity, resolving spontaneously without dose adjustment or discontinuation. Serum bilirubin elevations also occurred but the rates of elevations above 1.5 times ULN were similar to that in placebo controls (2.0% vs 1.4%) and the elevations were transient and not associated with concurrent GGT elevations. In the trial, serious adverse events arose in 7% of givinostat-treated vs 3% of placebo controls, but none of the severe events were hepatic. Similarly, 4% of givinostat-treated vs none of the placebo controls discontinued therapy, but none of the discontinuations were for liver-related events. There were no instances of clinically apparent liver injury in this controlled trial or in the patients receiving givinostat in other open label studies. Since approval of givinostat, there have been no published cases of liver injury attributed to the drug. Thus, despite having major hepatic metabolism, givinostat appears to cause little or no hepatic injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason that givinostat does not appear to cause liver injury despite extensive hepatic metabolism is not known. Givinostat is metabolized by multiple pathways that do not primarily involve the cytochrome P450 system or UDP-glucuronosyltransferases. As a class, the histone deacetylase inhibitors used in oncology have been associated with liver enzyme elevations and, rarely, hepatotoxicity, so a class effect cannot be entirely excluded. Because hepatic impairment is expected to raise givinostat exposure and the impact of impaired liver function has not been formally studied, caution is warranted in patients with underlying liver disease.

### Outcome and Management

Serum aminotransferase levels are unreliable as determinants of liver injury in patients with Duchenne muscular dystrophy and use of GGT as a marker of hepatic injury is probably more reliable. The product label for givinostat does not recommend monitoring GGT or other liver- related enzymes during therapy. However, marked elevations associated with symptoms or bilirubin elevations should lead to closer evaluation of liver injury and possible temporary discontinuation until the cause can be identified. There is no reason to suspect cross-sensitivity to liver injury among the various agents used to treat Duchenne muscular dystrophy including the anti-sense RNAs and viral vector directed gene therapy.

Drug Class: Genetic Disorder Agents; Duchenne Muscular Dystrophy Agents

Other Drugs used to treat Duchenne Muscular Dystrophy: Casimersen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Casimersen/), Eteplirsen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Eteplirsen/), Golodirsen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Golodirsen/), Viltolarsen (https://www.ncbi.nlm.nih.gov/books/n/livertox/Viltolarsen/), Delandistrogene Moxeparvovec (https://www.ncbi.nlm.nih.gov/books/n/livertox/DelandistrogeneMoxeparvovec/)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Givinostat – Duvyzat®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Givinostat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Givinostat | 497833-27-9 | C24H27N3O4 | SID: 389494007

## ANNOTATED BIBLIOGRAPHY

References updated: 16 September 2026

Abbreviations used: ULN, upper limit of normal; DMD, Duchenne muscular dystrophy; GGT, gamma-glutamyl transpeptidase; HDAC, histone deacetylase.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of antibiotics published in 1999, before the availability of givinostat).
Drugs@FDA. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217865Orig1s000IntegratedR.pdf (FDA website with the integrated multidisciplinary review of data on efficacy and safety of givinostat submitted in support of its approval as therapy of Duchenne muscular dystrophy mentions that in a placebo-controlled trial in 179 boys, results of elevations in ALT and AST were confounded by the pre-existing elevations in these enzymes in patients with muscular dystrophy because ALT and AST are also present in muscle and serum levels can fluctuate spontaneously, but there was no evidence for clinically significant liver injury with therapy based upon GGT levels and serum bilirubin elevations).
Lamb YN. Givinostat: first approval. Drugs. 2024;84:849-856. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of givinostat at the time of its approval for Duchenne muscular dystrophy, does not mention ALT elevations or hepatotoxicity). 38967716
Mercuri E, Vilchez JJ, Boespflug-Tanguy O, Zaidman CM, Mah JK, Goemans N, Müller-Felber W, et al.; EPIDYS Study Group. Safety and efficacy of givinostat in boys with Duchenne muscular dystrophy (EPIDYS): a multicentre, randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Neurol. 2024;23(4):393-403. (Among 179 ambulatory boys with Duchenne muscular dystrophy treated with givinostat or placebo for 72 weeks, decline in 4-stair climb time was less with givinostat [+1.25 sec] than placebo [+3.03 seconds], while severe adverse events were more frequent [7% vs 3%] none were hepatic; no mention of ALT elevations or hepatotoxicity). 38508835
Bettica P, Petrini S, D'Oria V, D'Amico A, Catteruccia M, Pane M, Sivo S, et al. Histological effects of givinostat in boys with Duchenne muscular dystrophy. Neuromuscul Disord. 2016;26(10):643-649. (Among 18 boys with Duchenne muscular dystrophy treated with givinostat and corticosteroids for at least 12 months, the muscle fiber area fraction increased by 29%, while fibrosis declined by 29% and fatty replacement by 38%; adverse events were mild to moderate with no mention of ALT elevations or hepatotoxicity). 27566866
Mercuri E, McDonald CM, Mah JK, Vandenborne K, et al. Long-term evaluation of givinostat in Duchenne muscular dystrophy, and natural history comparisons. Ann Clin Transl Neurol. 2025;12:2335-2348. (Ongoing open-label extension study evaluating the long-term safety, tolerability, and efficacy of givinostat with comparison to natural history data, suggesting a delay in major disease milestones and no hepatic safety signal was described with long-term treatment). 40830818
Xu J, Xiao C, Li L, Ma X, Xia S, Ji H, Shi F. Real-world safety profile of givinostat: an early post-marketing pharmacovigilance study based on the FAERS database. Front Pharmacol. 2026;17:1861893. (Among 402 spontaneous reports made to the FDA’s Adverse Event Reporting System [FAERS] during 2024 and 2025, the most frequent was decrease in platelet count [97], diarrhea [59], increase in triglycerides [45], nausea [31], and vomiting [30], and thrombocytopenia [28] while only 1 report was for hepatobiliary disorders). 42494524
Aartsma-Rus A. Histone deacetylase inhibition with givinostat: a multi-targeted mode of action with the potential to halt the pathological cascade of Duchenne muscular dystrophy. Front Cell Dev Biol. 2024;12:1514898. (Review of the multi-targeted mechanism of action of givinostat in Duchenne muscular dystrophy, describing histone deacetylase inhibition and its downstream effects on inflammation, fibrosis, fat accumulation, and muscle regeneration). 39834392

## OTHER REFERENCE LINKS

1. Recent References on Givinostat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=givinostat%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Givinostat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=givinostat)